# Boswellia Serrata

## OVERVIEW

### Introduction

Boswellia also called Indian Frankincense is an extract of the gummy oleoresin derived from beneath the bark of the Boswellia serrata tree, which is native to India, the Middle East and Northern Africa. The resin is rich in triterpenic acids and has been used for centuries in traditional Ayurvedic medicine to treat inflammatory conditions. More recently, Boswellia serrata extracts have been marketed as helpful in arthritis, colitis and asthma. Extracts of Boswellia serrata have not been linked to serum aminotransferase elevations during treatment or to instances of clinically apparent acute liver injury.

### Background

Boswellia serrata is a moderate sized deciduous tree that is native to India, the Middle East and Northern Africa. Stripping off the paper-thin bark of Boswellia trees reveals a gummy oleoresin, extracts of which have been used in Ayurvedic medicine for their antiinflammatory, antiseptic, astringent and stimulant activity to treat inflammatory conditions and gastrointestinal complaints. Boswellia extract is also used as a perfume and aroma (frankincense). Boswellia extract contains essential oils, terpenoids, sugars and volatile oils and prominently several pentacyclic triterpene acids such as beta boswellic acid. In vitro boswellic acid inhibits the synthesis of 5-lipooxygenase and decreases production of downstream pro-inflammatory mediators. Boswellia serrata extracts have been reported to be effective in alleviating symptoms of asthma, irritable bowel syndrome, inflammatory bowel disease and osteoarthritis, although the magnitude of these effects is not clear and Boswellia has not been approved for these uses in the United States. Boswellia serrata extracts are available over-the-counter in varying concentrations, the usual recommended dose being 250 to 500 mg two or three times daily. Boswellia serrata is also found in many multiingredient products advertised for joint health and gastrointestinal complaints. Side effects are few and largely mild and transient gastrointestinal symptoms of nausea, diarrhea or constipation. In most controlled studies, adverse events were no more frequent with Boswellia extracts than with placebo.

### Hepatotoxicity

Boswellia serrata extract has not been linked to serum enzyme elevations during therapy, although there have been few prospective studies in humans that have reported on its effects on laboratory test results in any detail. In small trials, Boswellia extracts have appeared to be well tolerated with only minor and few adverse effects which have been similar in frequency among persons receiving placebo. Despite wide scale use as an herbal supplement, Boswellia extract has not been convincingly linked to published instances of clinically apparent liver injury. Boswellia is often included in multi-ingredient dietary supplements some of which have been implicated in liver injury, but a specific contribution from Boswellia to the injury could not be established. The frequency of hypersensitivity reactions to Boswellia is also not known.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Other Names: Indian frankincense, Indian oli-banum, Salai guggul and Sallaki.

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Boswellia Serrata – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Boswellic Acid | 631-69-6 | C30-H48-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 03 November 2020

Abbreviation: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications linked to liver injury are discussed, but boswellia is not mentioned).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbals does not mention boswellia).
PDR for herbal medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007. (Compilation of short monographs on herbal medications and dietary supplements does not discuss Boswellia serrata).
Gupta I, Parihar A, Malhotra P, Singh GB, Lüdtke R, Safayhi H, Ammon HP. (1997). Effects of Boswellia serrata gum resin in patients with ulcerative colitis. Eur J Med Res. (Among 42 patients with ulcerative colitis treated with Boswellia gum resin [Salai guggal] or sulfasalazine for 6 weeks, clinical symptoms and histologic features improved in all and 18% on Boswellia had gastrointestinal side effects such as heartburn, anorexia, nausea or abdominal pain).
Gupta I, Gupta V, Parihar A, Gupta S, Lüdtke R, Safayhi H, Ammon HP. (1998). Effects of Boswellia serrata gum resin in patients with bronchial asthma: results of a double-blind, placebo-controlled, 6-week clinical study. Eur J Med Res. (Among 80 adults with asthma treated with Boswellia gum resin or placebo for 6 weeks, nearly all patients in both groups improved, but improvements in the Boswellia group were greater while only 2 subjects had side effects which were epigastric pain, hyperacidity and nausea).
Gupta I, Parihar A, Malhotra P, Gupta S, Lüdtke R, Safayhi H, Ammon HP. (2001). Effects of gum resin of Boswellia serrata in patients with chronic colitis. Planta Med. (Among 30 patients with chronic colitis treated with Boswellia serrata extract [900 mg daily] or sulfasalazine [3 g daily] for 6 weeks, improvements occurred in 90% of Boswellia- vs 60% of sulfasalazine-treated subjects and side effects were “minimal”; heartburn reported in two subjects, but no mention of ALT elevations or hepatotoxicity).
Gerhardt H, Seifert F, Buvari P, Vogelsang H, Repges R. (2001). Z Gastroenterol. (Among 83 patients with Crohn disease treated with Boswellia serrata extract or mesalazine for 8 weeks, changes in the Crohn Disease Activity Index with Boswellia were non-inferior to those with mesalazine and tolerance was excellent with no severe adverse events; no mention of ALT elevations or hepatotoxicity).
Kimmatkar N, Thawani V, Hingorani L, Khiyani R. (2003). Efficacy and tolerability of Boswellia serrata extract in treatment of osteoarthritis of knee--a randomized double blind placebo controlled trial. Phytomedicine. (Among 30 patients with osteoarthritis of the knee treated with Boswellia extract or placebo for 8 weeks followed by crossover, all subjects had improvement in pain scores and walking distance on the herbal extract and adverse events were largely mild and transient gastrointestinal complaints; no mention of ALT elevations or hepatotoxicity).
Chopra A, Lavin P, Patwardhan B, Chitre D. (2004). A 32-week randomized, placebo-controlled clinical evaluation of RA-11, an Ayurvedic drug, on osteoarthritis of the knees. J Clin Rheumatol. (Among 90 patients with osteoarthritis of the knee treated with a multiplant Ayurvedic product containing Boswellia serrata [with ashwagandha, ginger and curcumin] or a matched placebo for 32 weeks, pain scores improved more with the herbal supplement, and adverse events and changes in serum enzymes were mild and similar in the two groups).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, none were specifically attributed to a product containing Boswellia).
Langmead L, Rampton DS. (2006). Review article: complementary and alternative therapies for inflammatory bowel disease. Aliment Pharmacol Ther. (Review of complementary and alternative therapies for IBD mentions three trials of Boswellia serrata extracts in ulcerative colitis and Crohn disease, all of which reported moderate rates of remission, similar to standard therapies; no specific discussion of adverse events from Boswellia).
(2008). Boswellia serrata. Monograph. Altern Med Rev. (Brief review of Boswellia serrata, extracts of the gummy oleoresin from the Indian tree that has been used for centuries as an antiinflammatory agent, expectorant, astringent and antiseptic agent in Ayurvedic medicine that contains essential oils, terpenoids, sugars and volatile acids including beta-boswellic acid which has been shown to inhibit 5-lipooxygenase and have antiinflammatory, anti-elastase and anti-apoptotic activities).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, but none were attributed to Boswellia).
Navarro VJ. (2009). Herbal and dietary supplement hepatotoxicity. Semin Liver Dis. (Review of the problems of causality assessment in herbal and dietary supplement [HDS] associated liver disease, including the variable clinical presentations, the complexity and lack of information on their components, absence of controlled trials demonstrating safety and efficacy, the possibility of contamination or incorrect labeling, and the frequent underreporting of herbal use by patients. Regulation of HDS is under DSHEA, which requires manufacturers to determine safety and prohibits claims of efficacy in treating specific diseases. The US Pharmacopeia sets standards for food and drugs and includes HDS; HDS induced liver injury is a growing problem and currently accounts for at least 10% of cases of acute liver injury due to medications).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry; no mention of Boswellia).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, but none were attributed to Boswellia).
Holtmeier W, Zeuzem S, Preiss J, Kruis W, Böhm S, Maaser C, Raedler A, et al. (2011). Randomized, placebo-controlled, double-blind trial of Boswellia serrata in maintaining remission of Crohn's disease: good safety profile but lack of efficacy. Inflamm Bowel Dis. (Among 82 patients with Crohn disease in remission who were treated with Boswellia serrata extract or placebo for 52 weeks, the proportion of patients remaining in remission was similar in the two groups [60% vs 55%] as were rates of adverse events, and laboratory values showed no clinically significant changes in either group).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements, but Boswellia was not listed or mentioned).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to a product containing Boswellia).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], the single major herbal cause being green tea and none were attributed to Boswellia [Navarro et al. Hepatology 2014]).
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. (2016). Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci. (Listing of published cases of liver injury from HDS products, but does not mention or list Boswellia).
Brown AC. An overview of herb and dietary supplement efficacy, safety and government regulations in the United States with suggested improvements. Part 1 of 5 series. Food Chem Toxicol 2017; 107(Pt A): 449-71. (Summary of the US regulations on safety and efficacy of herbal and dietary supplements).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107(Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not mention or list Boswellia).
Navarro VJ, Khan I, Björnsson E, Seeff LB, Serrano J, Hoofnagle JH. (2017). Liver injury from herbal and dietary supplements. Hepatology. (Review of the problems of liver injury and HDS products, mentions that multiingredient dietary supplements account for the major of cases but does not mention a product with Boswellia as a component).
Karlapudi V, Prasad Mungara AVV, Sengupta K, Davis BA, Raychaudhuri SP. (2018). A placebo-controlled double-blind study demonstrates the clinical efficacy of a novel herbal formulation for relieving joint discomfort in human subjects with osteoarthritis of knee. J Med Food. (Among 105 patients with osteoarthritis of the knee treated with a herbal preparation containing Boswellia serrata extract or placebo, scores for pain, quality of life and physical function improved with the herbal supplement and there were no serious adverse events or mention of ALT elevations or hepatotoxicity).
Riva A, Giacomelli L, Togni S, Franceschi F, Eggenhoffner R, Zuccarini MC, Belcaro G. (2019). Oral administration of a lecithin-based delivery form of boswellic acids (Casperome®) for the prevention of symptoms of irritable bowel syndrome: a randomized clinical study. Minerva Gastroenterol Dietol. (Among 69 patients with mild forms of irritable bowel syndrome treated with Boswellia extract or placebo for 6 months, symptom scores for abdominal pain and altered bowel movements improved with the herbal extract and adverse events were mild and mostly “stipsis”; no mention of ALT elevations or hepatotoxicity).
Majeed M, Majeed S, Narayanan NK, Nagabhushanam K. (2019). A pilot, randomized, double-blind, placebo-controlled trial to assess the safety and efficacy of a novel Boswellia serrata extract in the management of osteoarthritis of the knee. Phytother Res. (Among 48 patients with osteoarthritis of the knee treated with Boswellia extract or placebo for 120 days, symptoms of pain and stiffness were improved with Boswellia and there were no “clinically significant” changes in laboratory values).

## OTHER REFERENCE LINKS

1 Recent References on Boswellia Serrata: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Boswellia%20Serrata+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Boswellia Serrata: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Boswellia%20Serrata)